# Bevacizumab (Antineoplastic)

## OVERVIEW

### Introduction

Bevacizumab is a humanized monoclonal antibody to human vascular endothelial growth factor (VEGF) and an anti-angiogenesis agent used in the therapy of colorectal, ovarian, renal and brain cancers. Bevacizumab has not been linked to serum enzyme elevations during therapy or to idiosyncratic acute liver injury. Bevacizumab may be partially protective against the vascular hepatic damage caused by other chemotherapeutic agents.

### Background

Bevacizumab (be” va siz’ ue mab) is a recombinant humanized monoclonal IgG1 antibody which is directed at and binds avidly to circulating vascular endothelial growth factor (VEGF). Receptors for VEGF (Flt-1 and KDR) are present on endothelial cells, and the engagement of VEGF with these receptors promotes angiogenesis. Inhibition of VEGF decreases formation of new blood vessels, which plays an important role in growth and spread of cancer cells. When used in combination with other antineoplastic agents, bevacizumab has been shown to extend both recurrence-free as well as overall patient survival in several forms of advanced cancer. Bevacizumab was approved in the United States in 2004 for use in metastatic colon cancer. Indications were subsequently extended to selected forms of non-small cell lung cancer, breast and renal cancer and glioblastoma. However, the indication for use in breast cancer was withdrawn in 2011 because of lack of evidence that bevacizumab extended overall patient survival. Bevacizumab is available vials of 100 or 400 mg (25 mg/mL) under the brand name Avastin. The typical dose is 5 to 10 mg/kg intravenously every 2 weeks or 7.5 to 15 mg every three weeks, usually in combination with other antineoplastic agents. Bevacizumab should be administered only by physicians with experience in using antineoplastic agents and managing their major complications. Bevacizumab has significant adverse side effects. Common adverse events include epistaxis, headache, dizziness, fatigue, hypertension, rhinitis, dry skin, back pain, excessive bleeding and skin rash. Rare complications include bowel, stomach or nasal septum perforation, poor wound healing, hemorrhage, thrombosis, renal dysfunction and ovarian failure.

### Hepatotoxicity

In large clinical trials, serum aminotransferase elevations were no more frequent in patients receiving bevacizumab than in those on placebo or receiving comparator agents. Subsequent to its approval and general use, bevacizumab has not been implicated in cases of idiosyncratic adult liver injury. Bevacizumab is generally given with other potent antineoplastic agents and to patients with hepatic metastases which makes it difficult to attribute serum enzyme elevations or clinically apparent liver injury to a specific agent being used. Nevertheless, significant liver injury from bevacizumab must be quite rare, if it occurs at all.

Because bevacizumab inhibits angiogenesis, it has the potential to inhibit hepatic regeneration and wound healing after hepatic surgery. However, when used in conjunction with other antineoplastic agents before resection for colorectal hepatic metastases, bevacizumab has been associated with less hepatic toxicity from the other antineoplastic agents (such as oxaliplatin, fluorouracil and irinotecan) and has not been associated with an increase in perioperative complications or operative mortality. Thus, inhibition of angiogenesis by bevacizumab may be beneficial in ameliorating the hepatic vascular injury caused by other antineoplastic agents. Indeed, bevacizumab has been reported to decrease the frequency of sinusoidal obstruction syndrome in patients receiving chemotherapy for colorectal liver metasstases.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which bevacizumab might cause liver injury is unclear. It is a recombinant protein and unlikely to be inherently hepatoxic, being metabolized to small polypeptides or amino acids by many cells and having no effect on activity of drug metabolizing enzymes or hepatic transporter molecules. Because it is an inhibitor of angiogenesis, it might be benefical in ameliorating hepatic vascular injury caused by other antigenoplastic agents.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

See also: Macular Degeneration Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bevacizumab – Avastin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Bevacizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Bevacizumab | 216974-75-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 26 September 2017

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 569-91 (Review of hepatotoxicity of immunosuppressive agents mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Hurwitz H, Fehrenbacher L, Novotny W, Cartwright T, Hainsworth J, Heim W, Berlin J, et al. Bevacizumab plus irinotecan, fluorouracil, and leucovorin for metastatic colorectal cancer. N Engl J Med 2004; 350: 2335-42. (Among 813 patients with metastatic colorectal cancer treated with irinotecan, fluorouracil and leucovorin [FOLFIRI] with or without bevacizumab, patient survival was longer with bevacizumab, but adverse events were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 15175435
Two new drugs for colon cancer. Med Lett Drugs Ther 2004; 46 (1184):46-8. (Concise review of mechanism of action, clinical efficacy, and cost of bevacizumab and cetuximab, two antineoplastic monoclonal antibodies, shortly after their approval in the US; adverse effects of bevacizumab include gastrointestinal bleeding or perforation, hypertension, pulmonary hemorrhage, thrombosis and asthenia; no mention of hepatotoxicity). 15184808
Donadon M, Vauthey JN, Loyer EM, Charnsangavej C, Abdalla EK. Portal thrombosis and steatosis after preoperative chemotherapy with FOLFIRI-bevacizumab for colorectal liver metastases. World J Gastroenterol 2006; 12: 6556-8. (61 year old woman with colorectal liver metastases received 6 courses of irinotecan, fluorouracil, leucovirin [FOLFIRI] and bevacizumab and CT scan showed portal branch thrombosis and fatty liver that required stopping chemotherapy and alteration of plans for resection of the metastasis). 17072991
Sanborn RE, Sandler AB. The safety of bevacizumab. Expert Opin Drug Saf 2006; 5: 289-301. (Review of the safety of bevacizumab focusing on hypertension, bleeding, thrombosis, proteinuria, neuropathy and gastrointestinal perforations; no discussion of ALT elevations or hepatotoxicity). 16503749
Ribero D, Wang H, Donadon M, Zorzi D, Thomas MB, Eng C, Chang DZ, et al. Bevacizumab improves pathologic response and protects against hepatic injury in patients treated with oxaliplatin-based chemotherapy for colorectal liver metastases. Cancer 2007; 110: 2761-7. (Among 105 patients with metastatic colorectal cancer undergoing preoperative chemotherapy [fluorouracil and oxaliplatin] before hepatic resection, the incidence and severity of hepatic sinusoidal dilation was less in those who also received bevacizumab [n=62; 27% any grade, 8% severe] than in those who did not [n=43; 54% any grade, 28% severe]). 17960603
D'Angelica M, Kornprat P, Gonen M, Chung KY, Jarnagin WR, DeMatteo RP, Fong Y, et al. Lack of evidence for increased operative morbidity after hepatectomy with perioperative use of bevacizumab: a matched case-control study. Ann Surg Oncol 2007; 14: 759-65. (Among 32 patients who underwent hepatic resection of colorectal cancer metastases who had received bevacizumab, perioperative complications and survival were similar to those of a matched, historical control group). 17103075
Bilchik AJ, Hecht JR. Perioperative risks of bevacizumab and other biologic agents for hepatectomy: theoretical or evidence based? J Clin Oncol 2008; 26: 1786-8. (Editorial on the concerns over the adverse effects of bevacizumab on wound healing and regeneration, mentioning that medical evidence is lacking on its specific adverse effects in using it with chemotherapy before hepatic resection of colorectal metastases). 18398144
Zorzi D, Chun YS, Madoff DC, Abdalla EK, Vauthey JN. Chemotherapy with bevacizumab does not affect liver regeneration after portal vein embolization in the treatment of colorectal liver metastases. Ann Surg Oncol 2008; 15: 2765-72. (Among 65 patients with metastatic colorectal cancer undergoing chemotherapy before portal vein embolization, liver remnant volume [measured by CT], hypertrophy in response to embolization, complications and outcomes were not different between the 26 who received bevacizumab and the 17 who did not). 18636296
Bevacizumab (Avastin) for metastatic breast cancer. Med Lett Drugs Ther 2008; 50 (1287): 42-3. (Concise review of the role of bevacizumab for metastatic breast cancer shortly after its approval for this indication by the FDA mentions that it may prolong recurrence free survival, but has not been shown to prolong overall survival; discussion of adverse events does not mention hepatotoxicity or ALT elevations). 18509265
Klinger M, Eipeldauer S, Hacker S, Herberger B, Tamandl D, Dorfmeister M, Koelblinger C, et al. Bevacizumab protects against sinusoidal obstruction syndrome and does not increase response rate in neoadjuvant XELOX/FOLFOX therapy of colorectal cancer liver metastases. Eur J Surg Oncol 2009; 35: 515-20. (Among 106 patients with metastatic colorectal cancer undergoing preoperative chemotherapy before hepatic resection, bevacizumab therapy [n=50] was associated with less sinusoidal dilatation [both frequency and severity], but rates of steatosis, fibrosis and tumor response were similar in the two groups). 19200687
Aussilhou B, Dokmak S, Faivre S, Paradis V, Vilgrain V, Belghiti J. Preoperative liver hypertrophy induced by portal flow occlusion before major hepatic resection for colorectal metastases can be impaired by bevacizumab. Ann Surg Oncol 2009; 16: 1553-9. (Measurement of hepatic volume before and after portal vein embolization in preparation for resection of hepatic colorectal metastasis found that 13 patients who received bevacizumab and extended chemotherapy had less hypertrophy in response to embolization that those who did not receive bevacizumab). 19363584
Vauthey JN, Zorzi D. In search of the black sheep: is it bevacizumab or extended chemotherapy? Ann Surg Oncol 2009; 16: 1463-4. (Editorial in response to Aussilhou [2009] questioning whether bevacizumab or extended chemotherapy with oxaliplatin or irinotecan was responsible for the finding of impaired liver regeneration after portal embolization in reparation for hepatic resection of metastases). 19357926
Scoggins CR, Campbell ML, Landry CS, Slomiany BA, Woodall CE, McMasters KM, Martin RC. Preoperative chemotherapy does not increase morbidity or mortality of hepatic resection for colorectal cancer metastases. Ann Surg Oncol 2009; 16: 35-41. (Among 186 patients with metastatic colorectal cancer who underwent hepatic resection between 1996 and 2006 at a single US referral center, there were no differences in complications, mortality or overall survival between the 112 who received preoperative chemotherapy and the 74 who did not). 18987915
Di Fiore F, Van Cutsem E. Acute and long-term gastrointestinal consequences of chemotherapy. Best Pract Res Clin Gastroenterol 2009; 23: 113-24. (Review of acute liver adverse events from cancer chemotherapy focusing on the effects of preoperative chemotherapy for colorectal cancer metastases and effects of irinotecan and oxaliplatin). 19258191
Cleary JM, Tanabe KT, Lauwers GY, Zhu AX. Hepatic toxicities associated with the use of preoperative systemic therapy in patients with metastatic colorectal adenocarcinoma to the liver. Oncologist 2009; 14: 1095-105. (Review of toxicities of preoperative chemotherapy for metastatic colorectal cancer including steatohepatitis after irinotecan [4-20%] and sinusoidal dilatation after oxaliplatin [10-78%], as well as the relative safety of bevacizumab and data showing that it may protect against sinusoidal damage and concerns over whether it may interfere with hepatic regeneration). 19880627
Rubbia-Brandt L, Lauwers GY, Wang H, Majno PE, Tanabe K, Zhu AX, Brezault C, et al. Sinusoidal obstruction syndrome and nodular regenerative hyperplasia are frequent oxaliplatin-associated liver lesions and partially prevented by bevacizumab in patients with hepatic colorectal metastasis. Histopathology 2010; 56: 430-9. (Among 274 patients with metastatic colorectal cancer undergoing preoperative chemotherapy [oxaliplatin] before hepatic resection, moderate to severe sinusoidal dilatation and injury was less common in those who received bevacizumab [n=70; 31%] than in those who did not [n=204; 62%], as was nodular regenerative hyperplasia [11% vs 29%] and centrilobular fibrosis [31% vs 52%], and these hepatic abnormalities were not found in 110 patients who did not undergo preoperative chemotherapy). 20459550
Zalinski S, Bigourdan JM, Vauthey JN. [Does bevacizumab have a protective effect on hepatotoxicity induced by chemotherapy?]. J Chir (Paris) 2010; 147 Suppl 1: S18-24. (Commentary on the possibility that antiangiogenesis effects of bevacizumab might affect wound healing and hepatic regeneration after resection of hepatic metastases, suggesting that the surgery be delayed until 5 weeks after completion of chemotherapy). 20172201
Pessaux P, Panaro F, Casnedi S, Zeca I, Marzano E, Bachellier P, Jaeck D, Chenard MP. Targeted molecular therapies (cetuximab and bevacizumab) do not induce additional hepatotoxicity: preliminary results of a case-control study. Eur J Surg Oncol 2010; 36: 575-82. (Among 36 patients with colorectal cancer undergoing hepatic resection after chemotherapy, steatohepatitis was less frequent in 21 patients who received bevacizumab than matched controls [5% vs 33%], and sinusoidal obstruction syndrome was less frequent in 15 patients given cetuximab than controls [0% vs 33%]). 20452168
Pessaux P, Marzano E, Casnedi S, Bachellier P, Jaeck D, Chenard MP. Histological and immediate postoperative outcome after preoperative cetuximab: case-matched control study. World J Surg 2010; 34: 2765-72. (Among 26 patients with metastatic colorectal cancer undergoing preoperative chemotherapy who also received cetuximab, serum enzyme and bilirubin elevations were similar to 26 matched control patients, and liver histology showed no differences in rates of steatohepatitis, sinusoidal obstruction syndrome or fibrosis). 20652697
Chaudhury P, Hassanain M, Bouganim N, Salman A, Kavan P, Metrakos P. Perioperative chemotherapy with bevacizumab and liver resection for colorectal cancer liver metastasis. HPB (Oxford) 2010; 12: 37-42. (Among 35 patients with metastatic colorectal cancer who received bevacizumab before hepatic resection of liver metastases, 9 also received irinotecan, but only 4 developed steatohepatitis and 2 jaundice postoperatively, but relationship of these events to irinotecan was not provided). 20495643
Lehmann K, Rickenbacher A, Weber A, Pestalozzi BC, Clavien PA. Chemotherapy before liver resection of colorectal metastases: friend or foe? Ann Surg 2012; 255: 237-47. (Systematic review of literature on efficacy and safety of preoperative chemotherapy before resection of colorectal hepatic metastases concludes that downsizing chemotherapy may offer a chance of secondary resection in about a third of patients). 22041509
Robinson SM, Wilson CH, Burt AD, Manas DM, White SA. Chemotherapy-associated liver injury in patients with colorectal liver metastases: a systematic review and meta-analysis. Ann Surg Oncol 2012; 19: 4287-99. (Systematic review of literature on chemotherapy induced liver injury in patients with colorectal cancer; oxaliplatin regimens are associated with a higher rate of sinusoidal injury [17% vs 6%] but not steatosis [11.5% vs 9.8%], and rates are reduced by concurrent bevacizumab therapy). 22766981
Noguchi Y, Tsurushima M, Tamura Y, Aoyama K, Tokuyama Y, Uchiyama K, Shimizu Y. [A case of hepatitis B virus reactivation in a patient with prior resolved hepatitis B infection during bevacizumab plus FOLFIRI treatment]. Gan To Kagaku Ryoho 2013; 40: 1561-3. Japanese. (Abstract: 74 year old man with metastatic colorectal cancer who had anti-HBc without HBsAg in serum developed reactivation of hepatitis B 42 days after the 21st cycle of bevacizumab and FOLFIRI with HBsAg, HBeAg and high levels of HBV DNA progressing to acute liver failure and death). 24231716
Constantinidou A, Cunningham D, Shurmahi F, Asghar U, Barbachano Y, Khan A, Mudan S, et al. Perioperative chemotherapy with or without bevacizumab in patients with metastatic colorectal cancer undergoing liver resection. Clin Colorectal Cancer 2013; 12: 15-22. (Among 94 patients with metastatic colorectal cancer undergoing preoperative chemotherapy, rates of complications of hepatic resection were similar in those who had received bevacizumab [48% overall, 12% severe] and those who did not [54% overall, 13% severe]. 23021126
Hubert C, Sempoux C, Humblet Y, van den Eynde M, Zech F, Leclercq I, Gigot JF. Sinusoidal obstruction syndrome (SOS) related to chemotherapy for colorectal liver metastases: factors predictive of severe SOS lesions and protective effect of bevacizumab. HPB (Oxford) 2013; 15: 858-64. (Retrospective analysis of 151 patients with colorectal cancer and hepatic metastases; some degree of sinusoidal obstruction syndrome occurred in 60 of 67 [90%] of those who received oxaliplatin and fluorouracil alone and was severe in 37 [55%], but arose in only 6 of 10 [60%] who also received bevacizumab and was severe in only 1 [10%]). 23458554
Maestraggi Q, Bouattour M, Toquet S, Jaussaud R, Kianmanesh R, Durand F, Servettaz A. Bevacizumab to treat cholangiopathy in hereditary hemorrhagic telangiectasia: be cautious: a case report. Medicine (Baltimore) 2015; 94: e1966. (61 year old woman with hereditary hemorrhagic telangiectasia treated with bevacizumab to inhibit angiogenesis developed hepatic vein thrombosis and multiple pulmonary emboli, possibly complications of the monoclonal antibody treatment). 26579805

## OTHER REFERENCE LINKS

1. Recent References on Bevacizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bevacizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bevacizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bevacizumab)